# Lisinopril

## OVERVIEW

### Introduction

Lisinopril is an angiotensin-converting enzyme (ACE) inhibitor widely used in the therapy of hypertension and heart failure. Lisinopril is associated with a low rate of transient serum aminotransferase elevations and has been linked to rare instances of acute liver injury that can be severe and even fatal.

### Background

Lisinopril (lye sin' oh pril) was the third ACE inhibitor to be approved for use in the United States and is still widely used for therapy of hypertension and heart failure. Like other ACE inhibitors, lisinopril inhibits the conversion of angiotensin I, a relatively inactive molecule, to angiotensin II which is the major mediator of vasoconstriction and volume expansion induced by the renin-angiotensin system. Other enzymes besides that which converts angiotensin I to II may also be inhibited, which may account for some of the side effects of the ACE inhibitors. Lisinopril was approved for use in the United States in 1987 and is currently one of the most widely prescribed medications in clinical practice, with more than 60 million prescriptions filled yearly. Current indications include hypertension, heart failure and to improve survival after acute myocardial infarction. Lisinopril is available in 2.5, 5, 10, 20, 30 and 40 mg tablets in many generic forms and under the trade names Prinivil and Zestril. The recommended initial dose in adults is 5 to 10 mg daily with subsequent adjustments based upon blood pressure response and tolerance. The average maintenance dose for hypertension is 20 to 40 mg once daily; the maximum recommended dose is 80 mg daily. Lower doses are recommended for heart failure and for chronic therapy after an acute myocardial infarction. Lisinopril is also available in fixed combinations with hydrochlorothiazide (generically and as Prinzide and Zestoretic). Common side effects include dizziness, fatigue, headache, cough, gastrointestinal upset and skin rash.

### Hepatotoxicity

Lisinopril, like other ACE inhibitors, has been associated with a low rate of serum aminotransferase elevations (<2%) that, in controlled trials, was no higher than with placebo therapy. These elevations were transient and rarely required dose modification. Rare instances of clinically apparent acute liver injury have been reported in association with lisinopril therapy. Despite its widescale use, fewer than a dozen cases of clinically apparent acute liver injury attributed to lisinopril therapy have been published. The latency to onset has ranged from 2 to 48 weeks and the pattern of serum enzyme elevations has been hepatocellular, in contrast to the typical cholestatic pattern that occurs wtih other ACE inhibitors. Immunoallergic manifestations (rash, fever, eosinophilia) are infrequent and most patients do not develop autoantibodies. Several reported cases were associated with signs of acute liver failure and deaths from complications have been reported.

Likelihood score: B (likely but rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the minor serum aminotransferase elevations associated with lisinopril therapy is not known. The cases of clinically apparent liver injury due to lisinopril are idiosyncratic and likely due to a reaction to a minor metabolite. Lisinopril has minimal hepatic metabolism.

### Outcome and Management

Most instances of acute liver injury reported with lisinopril use have been self limited, but there have been reports of acute liver failure and death. Patients with severe lisinopril induced acute liver injury should avoid use of other ACE inhibitors, although cross sensitivity to liver injury among the members of this class of agents has rarely been shown and, in some cases of lisinopril associated liver injury, patients had previously tolerated other ACE inhibitors.

References to the safety and potential hepatotoxicity of lisinopril are given in the Overview section on the Angiotensin-Converting Enzyme (ACE) Inhibitors.

Drug Class: Antihypertensive Agents, Angiotensin-Converting Enzyme Inhibitors

## CASE REPORT

### Case 1. Acute hepatitis due to lisinopril.

[Modified from: Larrey D, Babany G, Bernuau J, Andrieux J, DeGott C, Pessayre D, Benhamou J-P. Fulminant hepatitis after lisinopril administration. Gastroenterology 1990; 99: 1832-3.] PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/2172073)]

A 55 year old man developed fever and myalgias 1 week and jaundice 2 weeks after switching antihypertensive medications from enalapril (given for 1.5 years) to lisinopril (20 mg daily). He had no history of liver disease, alcohol abuse or risk factors for viral hepatitis. He was also taking bisoprolol (a beta blocker, for 5 months) and furosemide (a diuretic, for one year) for blood pressure control. Physical examination was normal except for jaundice. Laboratory tests showed a total bilirubin of 18.5 mg/dL, ALT 2510 U/L, and prothrombin index of 90% (Table: alkaline phosphatase levels not given). Furosemide was stopped, but lisinopril and bisoprolol were continued for another 3 weeks during which his jaundice worsened and he developed ascites, at which point he was admitted and all medications were stopped. His serum bilirubin had risen to 40.3 mg/dL and prothrombin index had fallen to 20%. He had no eosinophilia and tests for hepatitis A, B and C markers were negative. Serum antinuclear antibody was negative, but smooth muscle antibodies were reactive (1:100). A liver biopsy showed severe hepatic necrosis (largely centrolobular: zone 3) and marked cholestasis with no fibrosis. He developed severe jaundice, mild hepatic encephalopathy and persistent prolongation of prothrombin time compatible with acute liver failure. Approximately 6 weeks after onset, he began to recover spontaneously with decrease in serum bilirubin, improvement in prothrombin index, and resolution of hepatic encephalopathy. However, he developed an acute abdominal crisis and underwent emergency surgery which showed a perforated duodenal ulcer. Postoperatively, he developed septicemia and gastrointestinal bleeding and died approximately 2 months after initial presentation.

#### Key Points

Medication: | Lisinopril (20 mg daily)
Pattern: | Hepatocellular
Severity: | 5+ (hepatic failure, death)
Latency: | One week to symptoms, 2 weeks to jaundice
Recovery: | None
Other medications: | Furosemide, bisoprolol, enalapril previously

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Protime | Bilirubin (mg/dL) | Other
2 weeks | 0 | 2510 | 90% | 18.5 | Furosemide stopped
5 weeks | 3 weeks | 2561 | 20% | 40.3 | Lisinopril stopped
6 weeks | 4 weeks | 520 | 30% | 37.4
8 weeks | 6 weeks | 97 | 42% | 70.1
11 weeks | 9 weeks | 52 | 60% | 13.9 | Emergency surgery
Normal Values | | <40 | >90% | <1.2

#### Comment

The patient developed an acute hepatitis like syndrome between 1 and 2 weeks after switching his ACE inhibitor therapy of hypertension from enalapril to lisinopril. Lisinopril was, unfortunately, continued even after he developed jaundice and his liver injury worsened as shown by progressive cholestasis and signs and symptoms of hepatic failure. Once lisinopril was stopped, recovery began but was delayed and slow, and he suffered an acute and fatal complication while recovering. While rare, instances of acute liver failure have been described with the use of ACE inhibitors, largely those in wide use such as lisinopril, enalapril and captopril. The clinical presentation with acute liver failure is much less common than the typical cholestatic pattern of drug induced liver injury due to ACE inhibitors, but both patterns are exceedingly rare.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lisinopril – Generic, Prinivil®, Zestril®

DRUG CLASS

Angiotensin-Converting Enzyme Inhibitors

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Lisinopril)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Lisinopril | 83915-83-7 | C21-H31-N3-O5.2H2-O | Lisinopril Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Lisinopril: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Lisinopril/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Lisinopril: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Lisinopril)